# Chenodiol (Chenodeoxycholic Acid)

## OVERVIEW

### Introduction

Chenodeoxycholic acid (chenodiol) is a primary bile acid, synthesized in the liver and present in high concentrations in bile that is used therapeutically to dissolve cholesterol gallstones. Chronic therapy is associated with transient elevations in serum aminotransferase levels in up to 30% of patients, but chenodiol has been linked to only rare instances of clinically apparent liver injury with jaundice.

### Background

Chenodeoxycholic acid or chenodiol (kee" noe dye' ol) is a naturally occurring bile acid that is used therapeutically to dissolve cholesterol gallstone in patients with a functioning gall bladder who have contraindications to cholecystectomy or refuse surgery. Chenodiol is the major bile acid synthesized by the liver and is usually the bile acid in highest concentration in serum, hepatocytes and bile. When given orally, chenodiol is passively absorbed from the small intestine and taken up by the liver via anion transport proteins. High concentrations of chenodiol in liver decrease the hepatic synthesis of both cholesterol and other bile acids, thereby increasing the cholic acid and decreasing cholesterol concentration in bile. This combination of events results in a decrease in cholesterol saturation of bile, the major impetus to the formation of cholesterol gallstones. When given for 2 years or more, chenodeoxycholic acid can dissolve cholesterol gallstones in 15% to 30% of patients. Chenodiol is most effective on small “floating” gallstones. It is not effective for calcified gallstones or in patients with a non-functioning gallbladder. Even with successful therapy, however, gallstone recurrence is as high as 50% within a few years of stopping chenodiol. Chenodiol was approved for use in patients with radiolucent gallstones in 1983 and remains available, although it has largely been replaced by ursodiol which appears to be more effective and is better tolerated. In addition, the introduction of laparoscopic cholecystectomy has markedly decreased the need for medical therapy of gallstones. Chenodiol is available as tablets of 250 mg generically and under the commercial names Chenix and Chenodal. The recommended dose is 13 to 16 mg/kg daily in two divided doses for up to 2 years. Side effects include gastrointestinal upset with diarrhea, bloating, cramps, dyspepsia, nausea and vomiting.

### Hepatotoxicity

In multiple clinical trials of chenodiol therapy for dissolution of gallstones, serum aminotransferase elevations occurred in up to 30% of patients. The elevations generally arose within 2 months of starting therapy and were typically mild, transient and not accompanied by symptoms or jaundice. Liver biopsies done during chenodiol therapy generally showed mild, nonspecific changes. Clinically apparent liver injury with jaundice was not reported. The liver enzyme elevations were generally dose related and usually did not recur on restarting chenodiol at lower doses. While the serum enzyme abnormalities that occurred on chenodiol therapy generated considerable concern, they appeared to be relatively benign. Since the approval of chenodiol and its more widespread use, at least four instances of liver injury with jaundice have been reported to the sponsor, but the clinical features and outcomes of these cases have not been published. Nevertheless, the product label for chenodiol includes a boxed warning about hepatotoxicity although it does not provide advice on the frequency or how to respond to abnormalities. Thus, the reliability of reports of clinically apparent liver injury with chenodiol therapy remains unclear. Once ursodiol was found to be equally as effective as chenodiol, even at lower doses, and was rarely associated with serum enzyme elevations, it rapidly replaced chenodiol as medical therapy for gallstones.

Likelihood score: E* (Suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Chenodiol is thought to cause serum aminotransferase elevations because of conversion to lithocholic acid which has intrinsic, proven hepatotoxicity. In animal models, chenodiol is less hepatotoxic than lithocholic acid, but is more injurious than ursodiol. The more marked hepatotoxicity of chenodiol and lithocholic acid in rodent and primate models compared to humans has been attributed to a more effective sulfation of lithocholic acid in humans that renders it more water soluble, less toxic and more readily excreted.

### Outcome and Management

Patients on chenodiol should be monitored with liver tests, including serum bilirubin, ALT, AST and alkaline phosphatase at periodic intervals. Chenodiol should be discontinued for persistent increases in liver test abnormalities, ALT elevations above 8 times the upper limit of normal, elevations of bilirubin more than twice normal or any symptom or sign of liver injury. Replacing chenodiol with ursodiol is probably appropriate in that there does not appear to be cross sensitivity to liver injury or adverse events between chenodiol and other therapeutic bile acids.

Other bile acids used in digestive diseases include cholic acid, obeticholic acid and ursodeoxycholic acid (ursodiol).

Drug Class: Gastrointestinal Agents, Bile Acids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chenodiol – Generic, Chenodal®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chenodiol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chenodiol | 474-25-9 | C24-H40-O4 | Chenodiol Chemical Structure
Cholic Acid | 81-25-4 | C24-H40-O5 | Chenodiol Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 09 September 2016

Abbreviations used: FXR, farnesoid X receptor; NAFLD, nonalcoholic fatty liver disease; NASH, nonalcoholic steatohepatitis; OCA, obeticholic acid; PBC, primary biliary cirrhosis (cholangitis).

Zimmerman HJ. Bile acid derivatives. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999; mentions that chenodiol led to aminotransferase elevations in 30-50% of patients and at least 4 instances of overt hepatitis occurred in recipients, but it has been largely replaced by ursodiol which has been associated with only “trivial” elevations in ALT levels).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Danzinger RG, Hofmann AF, Schoenfield LJ, Thistle JL. Dissolution of cholesterol gallstones by chenodeoxycholic acid. N Engl J Med 1972; 286: 1-8. (Among 7 women with radiolucent gallstones treated with chenodiol, gallstone dissolution [n=1] or decrease in size [n=3] occurred in 4 patients and side effects included diarrhea, and “mild transient elevations of [AST and Alk P] were seen in several patients but liver biopsies were normal at 6 and 12 months”). 5006919
Thistle JL, Hofmann AF. Efficacy and specificity of chenodeoxycholic acid therapy for dissolving gallstones. N Engl J Med 1973; 289: 655-9. (Among 53 patients with radiolucent gallstones treated with chenodiol, cholic acid or placebo for 6 months, stone size decreased in 61% of chenodiol, but in none of the cholic acid or placebo recipients; AST elevations above twice ULN occurred in 29% of patients, but levels returned to normal despite continuing treatment). 4580472
Schoenfield LJ. Medical therapy for gallstones. Gastroenterology 1974; 67 (4): 725-9. (Review of the frequency, epidemiology, pathogenesis and possible medical therapies for gallstone disease mention promising results from small trials of chenodiol, but that up to 25% of patients develop ALT elevations during treatment, although the elevations are usually transient and invariably without jaundice or clinical symptoms). 4606798
Morrissey KP, McSherry CK, Swarm RL, Nieman WH, Deitrick JE. Toxicity of chenodeoxycholic acid in the nonhuman primate. Surgery 1975; 77: 851-60. (Among 18 baboons treated with chenodiol [18-38 mg/kg daily], 15 [83%] had ALT or AST elevations, most of whom had “significant” histologic changes, similar to those described for lithocholic acid). 1145445
Gadacz TR, Allan RN, Mack E, Hofmann AF. Impaired lithocholate sulfation in the rhesus monkey: a possible mechanism for chenodeoxycholate toxicity. Gastroenterology 1976; 70: 1125-9. (Turnover studies of radiolabeled lithocholate in rhesus monkeys showed minimal sulfation [17%] which may account for the toxicity of chenodiol in this species). 817960
Levy VG, Bouma ME, Lageron A, Darnis F, Infante R. Hepatic sinusoidal dilatation after chenodeoxycholic-acid therapy. Lancet 1978; 1 (8057): 206. (Among 26 patients with radiolucent gallstones treated with chenodiol for at least 12 months, there was an increase in the proportion with sinusoidal dilatation from 35% at baseline to 58% at 6 and 65% at 12 months, but the significance of this change was unclear). 74627
Hofmann AF, Thistle JL, Klein PD, Szczepanik PA, Yu PY. Chenotherapy for gallstone dissolution. II. Induced changes in bile composition and gallstone response. JAMA 1978; 239: 1138-44. (Chenodiol but not cholic acid or placebo therapy was associated with disease in cholesterol saturation of bile; the amount of change, however, did not correlate with success of therapy in dissolving gallstones). 628065
Thistle JL, Hofmann AF, Ott BJ, Stephens DH. Chenotherapy for gallstone dissolution. I. Efficacy and safety. JAMA 1978; 239: 1041-6. (Among 90 patients with radiolucent gallstones treated with chenodiol, response rates increased with time, with higher doses and smaller stones, mild elevations in AST occurred in 16% of patients but were transient, resolving with dose modification and not associated with jaundice or symptoms). 342729
Schoenfield LJ, Lachin JM. Chenodiol (chenodeoxycholic acid) for dissolution of gallstones: the National Cooperative Gallstone Study. A controlled trial of efficacy and safety. Ann Intern Med 1981; 95; 257-82. (Among 916 patients with radiolucent gallstones treated with chenodiol [350 or 750 mg daily] vs placebo for 2 years, gallstone dissolution occurred in 5% and 13.5% vs 0% and ALT elevations in 13-19% vs 13%, which were above 3 times ULN in 5-8% vs 4%, while biopsies showed nonspecific changes only; ALT elevations resolved even without stopping in most and among 17 who stopped therapy, 6 had recurrence on restarting; no patient developed clinically apparent liver injury). 7023307
Miyai K, Javitt NB, Gochman N, Jones HM, Baker D. Hepatotoxicity of bile acids in rabbits: ursodeoxycholic acid is less toxic than chenodeoxycholic acid. Lab Invest 1982; 46: 428-37. (Feeding rabbits chenodeoxycholic and lithocholic acid led to increases in ALT levels, histologic changes in the liver and significant mortality compared to no treatment or use of ursodiol). 7200166
Fisher RL, Anderson DW, Boyer JL, Ishak K, Klatskin G, Lachin JM, Phillips MJ. A prospective morphologic evaluation of hepatic toxicity of chenodeoxycholic acid in patients with cholelithiasis: the National Cooperative Gallstone Study. Hepatology 1982; 2: 187-201. (Among 126 patients with cholelithiasis treated with chenodiol for 24 months who underwent liver biopsies at 0, 9 and 24 months, minor nonspecific abnormalities were frequent, but did not correlate with ALT or AST elevations). 7068113
Roda E, Bazzoli F, Labate AM, Mazzella G, Roda A, Sama C, Festi D, et al. Ursodeoxycholic acid vs. chenodeoxycholic acid as cholesterol gallstone-dissolving agents: a comparative randomized study. Hepatology 1982; 2: 804-10. (Among 223 patients with gallstones treated with ursodiol or chenodiol at 2 doses for 12 months, rates of gallstone dissolution were similar at the higher doses, but were greater with ursodiol even at the lower doses; ALT elevations occurred only in chenodiol groups [14%], but there were no concurrent elevations in Alk P or bilirubin). 7141392
Fromm H, Roat JW, Gonzalez V, Sarva RP, Farivar S. Comparative efficacy and side effects of ursodeoxycholic and chenodeoxycholic acids in dissolving gallstones. A double-blind controlled study. Gastroenterology 1983; 85: 1257-64. (Among 60 patients with radiolucent gallstones treated with chenodiol [375 or 750 mg] or ursodiol [400 or 800 mg] or placebo daily, complete occurred in 7% on chenodiol versus 30% on ursodiol but none on placebo, while ALT elevations above 3 times ULN occurred in 2 of 26 on chenodiol but none of 24 on ursodiol). 6354826
Phillips MJ, Fisher RL, Anderson DW, Lan SP, Lachin JM, Boyer JL. Ultrastructural evidence of intrahepatic cholestasis before and after chenodeoxycholic acid therapy in patients with cholelithiasis: the national cooperative gallstone study. Hepatology 1983; 3: 209-20. (Among 103 patients with gallstones treated with chenodiol who underwent liver biopsies before and 9 and 24 months after starting therapy, minor changes in intrahepatic cholestasis were found in “almost every biopsy”, even those taken before treatment, but the degree of change tended to worsen with chenodiol therapy). 6832711
Erlinger S, Le Go A, Husson JM, Fevery J. Franco-Belgian cooperative study of ursodeoxycholic acid in the medical dissolution of gallstones: a double-blind, randomized, dose-response study, and comparison with chenodeoxycholic acid. Hepatology 1984; 4: 308-14. (Among 197 patients with radiolucent gallstones treated with ursodiol or chenodiol, stone dissolution rates were similar, but diarrhea was less with ursodiol [5% vs 23%]; ALT elevations were transient and mild [less than twice normal] in all except one patient [3%] on chenodiol). 6706305
Fisher MM, Roberts EA, Rosen IE, Shapero TF, Sutherland LR, Davies RS, Bacchus R, Lee SV. The Sunnybrook Gallstone Study: a double-blind controlled trial of chenodeoxycholic acid for gallstone dissolution. Hepatology 1985; 5: 102-7. (Among 160 patients with radiolucent gallstones treated with chenodiol [375 or 750 mg daily] or placebo for 2 years, stone dissolution occurred in 11-13% vs 0% and no patient developed clinically apparent liver injury). 3881327
Nakashima T, Sano A, Seto Y, Nakajima T, Okuno T, Takino T. A case of hyperbilirubinemia during treatment with chenodeoxycholic acid. Jpn J Med 1987; 26: 404-8. (A 27 year old woman with acute, symptomatic cholelithiasis developed jaundice within 6 weeks of starting chenodiol [peak values 12.8 mg/dL, ALT normal, Alk P ~3 times ULN], resolving upon stopping but later requiring cholecystectomy). 3694926
Fisher RL, Hofmann AF, Converse JL, Rossi SS, Lan SP. The lack of relationship between hepatotoxicity and lithocholic-acid sulfation in biliary bile acids during chenodiol therapy in the National Cooperative Gallstone Study. Hepatology 1991; 14: 454-63. (Testing of bile samples from 31 patients with gallstones treated with chenodiol with and without liver test or liver biopsy abnormalities showed no differences in lithocholate levels during treatment). 1874490
Poupon RE, Balkau B, Eschwège E, Poupon R. A multicenter, controlled trial of ursodiol for the treatment of primary biliary cirrhosis. UDCA-PBC Study Group. N Engl J Med 1991; 324: 1548-54. (Among 146 patients with PBC treated with ursodiol [13-15 mg daily] or placebo for 2 years, ALT, Alk P and bilirubin levels and liver histology [except for fibrosis] improved with ursodiol but not placebo; one patient on ursodiol required discontinuation because of worsening of pruritus; no mention of hepatotoxicity or other toxicities). 1674105
Bashir RM, Lewis JH. Hepatotoxicity of drugs used in the treatment of gastrointestinal disorders. Gastroenterol Clin North Am 1995; 24: 937-67. (Review of hepatotoxicity of drugs for gastrointestinal disease mentions that ALT elevations occur in up to 30% of patients treated with chenodiol, and are above 3-4 times ULN in 2-3% and that there have been at least 4 cases of clinically apparent liver injury reported to the sponsor whereas no such reports have been linked to ursodiol). 8749906
Bove KE, Heubi JE, Balistreri WF, Setchell KD. Bile acid synthetic defects and liver disease: a comprehensive review. Pediatr Dev Pathol 2004; 7: 315-34. (Extensive review of the inherited forms of defective bile acid synthesis which are often accompanied by progressive cholestatic liver injury, some of which respond to treatment with oral bile acids, including 3β-OH steroid dehydrogenase, 5β-reductase and mitochondrial C-27 hydroxylase deficiencies as well as several peroxisomal defects [Zellweger syndrome]). 15383928
Paumgartner G. Medical treatment of cholestatic liver diseases: From pathobiology to pharmacological targets. World J Gastroenterol 2006; 12: 4445-51. (Review of the pathogenesis of gallstone formation and medical therapies for gallstone dissolution). 16874853
Chiang JY. Bile acids: regulation of synthesis. J Lipid Res 2009; 50: 1955-66. (Review of the pathways of cholic and chenodeoxycholic acid synthesis and their regulation via FXR, FGF19, FGFR4 and CYP7A1). 19346330
Song P, Zhang Y, Klaassen CD. Dose-response of five bile acids on serum and liver bile acid concentrations and hepatotoxicty in mice. Toxicol Sci 2011; 123: 359-67. (Feeding of various concentrations of 5 different bile acids to mice demonstrated clear toxicity with lithocholic, cholic, deoxycholic and chenodeoxycholic acid, but little or no toxicity with ursodeoxycholic acid). 21747115
Heubi JE, Setchell KD, Jha P, Buckley D, Zhang W, Rosenthal P, Potter C, et al. Treatment of bile acid amidation defects with glycocholic acid. Hepatology 2015; 61: 268-74. (Among 5 children with inborn errors of bile acid synthesis [defective amidation] who were treated with glycocholic acid, all had improvements in fat soluble vitamin absorption and no worsening of liver injury). 25163551
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to chenodiol or other bile acid therapies). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Chenodiol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chenodiol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Chenodiol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chenodiol)